# Serotonin 5-HT4 Receptor Agonists

## OVERVIEW

### Introduction

The serotonin type 4 (5-HT4) receptor agonists are potent prokinetic agents that act on serotonin receptors in the intestine and promote intestinal peristalsis, increase gastric emptying and decrease esophageal reflux. Two 5-HT4 receptor agonists have been developed and were approved for use in the United States, but both were found to have significant serious adverse effects and have been withdrawn (cisapride) or placed under restricted use (tegaserod). Both cisapride and tegaserod have been associated with a low rate of transient serum enzyme elevations during therapy, but neither has been implicated convincing in cases of clinically apparent liver injury with jaundice.

### Background

Serotonin plays a major role in the normal motility and secretory function of the intestine and is produced by specialized enterochromaffin cells in the mucosa of the gut. Serotonin (5-HT) is released in response to chemical and mechanical stimulation and acts through the type 4 receptors that are common in the intestinal mucosa to increase peristalsis and intestinal tone. 5-HT4 receptors are also found in the central nervous system, urinary bladder and atria of the heart, which may explain some of their adverse effects. Two 5-HT4 receptor agonists have been developed and used in clinical medicine: cisapride and tegaserod.

Cisapride (sis’ a pride) is a piperidinyl benzamide and a potent 5-HT4 receptor agonist that was developed as a therapy for gastroesophageal reflux disease (GERD) and diabetic gastroparesis. In several clinical trials, cisapride was found to improve symptoms of bloating and gastric distension in patients with gastroparesis and decrease symptoms of reflux in patients with GERD. Cisapride was approved in the United States, but was subsequently withdrawn after multiple reports of life threatening arrhythmias associated with prolonged QTc syndrome. Cisapride had been available in tablets of 10 and 20 mg under the brand name of Propulsid. The usual recommended dose was 10 to 20 mg 3 to 4 times daily. Cisapride is still available on a limited basis in Europe and elsewhere. It is also available for use in animals for treatment of gastrointestinal status and megacolon.

Tegaserod (teg” a ser’ od) is an aminoguanidine indole derivative of serotonin and a selective, partial 5-HT4 receptor agonist. It simulates the peristaltic reflex and increases intestinal and colonic motility resulting in hastened transit. It also reduces visceral sensation in response to distension. These features led to its development as therapy of irritable bowel syndrome and constipation. It was approved for use in the United States in 2002 and was available in tablets of 2 or 6 mg under the brand name of Zelnorm. The typically recommended dose was 2 to 6 mg twice daily. Tegaserod was withdrawn in 2007 because of adverse cardiovascular effects, postmarketing studies demonstrating an excess of severe adverse cardiovascular events in tegaserod treated patients (0.11%) compared to matched controls (0.01%). The association of tegaserod with adverse cardiovascular events has been contested but, currently, tegaserod is available only on an emergency basis and with prior authorization from the FDA.

Prucalopride (proo kal' oh pride) is a unique chemical entity, a benzofurancarboxamide derivative which is highly selective for the serotonin type 4 receptor and differs from cisapride and tegaserod in having minimal activity against for other serotonin receptors. In multiple clinical trials, prucalopride was found to aleviate symptoms of chronic idiopathic constipation in a proportion of patients and had minimal adverse effects. Importantly, cardiac arrhythmias and prolongation of the QTc interval were not increased in frequency in patients receiving prucalopride. Prucalopride was approved as therapy of chronic idiopathic constipation in 2018 and is now generally available. Prucalopride is described in its own record in LiverTox.

### Hepatotoxicity

Both cisapride and tegaserod were linked to occasional instances of serum enzyme elevations during therapy (1% to 9%), but these elevations were generally mild and asymptomatic, resolving rapidly with or without discontinuing drug. While moderate serum enzyme elevations during 5-HT4 receptor agonist therapy have been described, there have been have been no convincing reports of clinically apparent acute liver injury with jaundice attributed to these agents. Plucalopride has not been linked to increased rates of serum enzyme elevations nor to instances of acute liver injury with jaundice, but experience with its long-term use has been limited.

Likelihood score: E (unlikely causes of clinically apparent liver injury).

### Mechanism of Injury

Cisapride is metabolized in the liver, largely via CYP 3A4, and it must be used with caution in patients taking medications that inhibit CYP 3A4 activity. Tegaserod is metabolized by the liver largely by glucuronidation and has little effect on cytochrome P450 activity and few drug-drug interactions.

Drug Class: Gastrointestinal Agents, Prokinetic Agents

Other Drugs in the Subclass, Prokinetic Agents: Prucalopride

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cisapride – Generic, Propulsid®

Tegaserod – Zelnorm®

Prucalopride – Motegrity®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cisapride)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Cisapride | 81098-60-4 | C23-H29-Cl-F-N3-O4 | Cisapride Chemical Structure
Tegaserod | 145158-71-0 | C16-H23-N5-O | Tegaserod Chemical Structure
Prucalopride | 179474-81-8 | C18-H26-Cl-N3-O3 | 2D chemical structure of 179474-81-8

## ANNOTATED BIBLIOGRAPHY

References updated: 25 April 2019

Zimmerman HJ. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 717-8. (Expert review of hepatotoxicity published in 1999 mentions that cisapride, a serotonin type 4 receptor agonist, was reported to lead to one case of liver injury [hepatocellular] during a decade of use).
Sharkey KA,McNcaughton WK. gastointestinal motility and water flux, emesis, and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics; the serotonin type 4 receptor agonists are used predominantly for treatment of diseases of intestinal motility and irritable bowel syndrome).
Havelund T, Oster-Jørgensen E, Eshøj O, Larsen ML, Lauritsen K. Effects of cisapride on gastroparesis in patients with insulin-dependent diabetes mellitus. A double-blind controlled trial. Acta Med Scand 1987; 222: 339-43. (Among 10 patients with diabetic gastroparesis treated in a double blind, 4 week cross over study of cisapride reported no side effects other than headache in one patient). 3321924
Camilleri M, Malagelada JR, Abell TL, Brown ML, Hench V, Zinsmeister AR. Effect of six weeks of treatment with cisapride in gastroparesis and intestinal pseudoobstruction. Gastroenterology 1989; 96: 704-12. (Among 26 patients with upper gut dysmotility treated with cisapride vs placebo, symptoms improved equally in both groups, although measured gastric emptying changed only with cisapride; side effects were not mentioned). 2644150
Galmiche JP, Fraitag B, Filoche B, Evreux M, Vitaux J, Zeitoun P, Fournet J, Soule JC. Double-blind comparison of cisapride and cimetidine in treatment of reflux esophagitis. Dig Dis Sci 1990; 35: 649-55. (Among 73 patients with erosive reflux esophagitis treated with cisapride or cimetidine, symptoms and mucosal healing occurred equally with either drug and side effects were mild; no mention of ALT levels or hepatotoxicity). 2331957
Abell TL, Camilleri M, DiMagno EP, Hench VS, Zinsmeister AR, Malagelada JR. Long-term efficacy of oral cisapride in symptomatic upper gut dysmotility. Dig Dis Sci 1991; 36: 616-20. (Among 21 patients with gastroparesis treated with cisapride for 12 months, "no significant side effects were noted"). 2022163
Denié C, Gohy P. [Cytolytic hepatitis induced by cisapride]. Gastroenterol Clin Biol 1992; 16: 368-9. French. (A 67 year old man with GERD developed nausea 4 days after starting cisapride, and one week later was still symptomatic and was found to have abnormal liver tests [bilirubin 1.2 mg/dL, ALT 11 times ULN, Alk P 1.2 times ULN, normal amylase], abnormalities resolving within 3 weeks of stopping). 1397860
Richards RD, Valenzuela GA, Davenport KG, Fisher KL, McCallum RW. Objective and subjective results of a randomized, double-blind, placebo-controlled trial using cisapride to treat gastroparesis. Dig Dis Sci 1993; 38: 811-6. (Among 38 patients with gastroparesis treated with cisapride or placebo for 6 weeks, there was "no significant change in any of the measured laboratory parameters relative to baseline"). 8482178
Dworkin BM, Rosenthal WS, Casellas AR, Girolomo R, Lebovics E, Freeman S, Clark SB. Open label study of long-term effectiveness of cisapride in patients with idiopathic gastroparesis. Dig Dis Sci 1994; 39: 1395-8. (In an open label study in 11 patients with idiopathic gastroparesis treated with cisapride for 12 months, "no significant side effects of cisapride, either in clinical or laboratory data, were observed"). 8026248
Kellow JE, Cowan H, Shuter B, Riley JW, Lunzer MR, Eckstein RP, Höschl R, et al. Efficacy of cisapride therapy in functional dyspepsia. Aliment Pharmacol Ther 1995; 9: 153-60. (Among 74 patients treated with cisapride or placebo for 4 weeks, adverse events were "generally mild" and hepatotoxicity and ALT levels were not mentioned). 7605855
Richter JE, Long JF. Cisapride for gastroesophageal reflux disease: a placebo-controlled, double-blind study. Am J Gastroenterol 1995; 90: 423-30. (Among 177 patients with GERD treated with cisapride or placebo for 2 weeks, adverse events included diarrhea and constipation, and "no significant changes occurred in values for...clinical laboratory variables"). 7872282
Bashir RM, Lewis JH. Hepatotoxicity of drugs used in the treatment of gastrointestinal disorders. Gastroenterol Clin North Am 1995; 24: 937-67. (Review of evidence of hepatotoxicity of gastrointestinal drugs includes mention that cisapride showed no evidence of hepatotoxicity in prelicensure studies and that only a single case of hepatotoxicity attributed to cisapride has been published [Denié 1992]). 8749906
Castell DO, Sigmund C Jr, Patterson D, Lambert R, Hasner D, Clyde C, Zeldis JB. Cisapride 20 mg b.i.d. provides symptomatic relief of heartburn and related symptoms of chronic mild to moderate gastroesophageal reflux disease. CIS-USA-52 Investigator Group. Am J Gastroenterol 1998; 93: 547-52. (Among 398 patients with symptomatic GERD treated with cisapride or placebo for 4 weeks, diarrhea was more common with cisapride [10% vs 4%]; laboratory testing results were not mentioned). 9576446
Castell D, Silvers D, Littlejohn T, Orr W, Napolitano J, Oleka N, Jokubaitis L. Cisapride 20 mg b.d. for preventing symptoms of GERD induced by a provocative meal. The CIS-USA-89 Study Group. Aliment Pharmacol Ther 1999; 13: 787-94. (Among 122 patients treated with cisapride or placebo for 7 days, diarrhea occurred in 18% of cisapride vs 0% of placebo recipients; laboratory measurements were not done). 10383509
Tougas G, Snape WJ Jr, Otten MH, Earnest DL, Langaker KE, Pruitt RE, Pecher E, et al. Long-term safety of tegaserod in patients with constipation-predominant irritable bowel syndrome. Aliment Pharmacol Ther 2002; 16: 1701-8. (Among 567 patients with constipation predominant IBS treated with tegaserod for up to 12 months, common adverse events were diarrhea [10%], headache [8%], and abdominal pain [7%], but blood tests results were "generally unremarkable" and no serious hepatic adverse events occurred). 12269961
Hasler WL, Schoenfeld P. Safety profile of tegaserod, a 5-HT4 receptor agonist, for the treatment of irritable bowel syndrome. Drug Saf 2004; 27: 619-31. (Review of the safety of tegaserod in IBS mentions that laboratory parameters were "mostly unaffected by tegaserod"). 15230644
Nyhlin H, Bang C, Elsborg L, Silvennoinen J, Holme I, Rüegg P, Jones J, et al. A double-blind, placebo-controlled, randomized study to evaluate the efficacy, safety and tolerability of tegaserod in patients with irritable bowel syndrome. Scand J Gastroenterol 2004; 39: 119-26. (Among 643 patients with IBS treated with tegaserod [6 mg twice daily] or placebo for 12 weeks, diarrhea [9.2% vs 1.3%] and headache [8% vs 4.7%] were more frequent with tegaserod, but laboratory data .did not raise any issues.). 15000272
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to prokinetic agents or the 5-HT4 receptor agonists). 15390328
Müller-Lissner S, Kamm MA, Musoglu A, Earnest DL, Dunger-Baldauf C, Shetzline MA. Safety, tolerability, and efficacy of tegaserod over 13 months in patients with chronic constipation. Am J Gastroenterol 2006; 101: 2558-69. (Among 842 patients with chronic constipation treated in an open label extension study with tegaserod [2 or 6 mg twice daily] for up to 13 months, side effects included headache, abdominal pain, diarrhea, nausea, and ALT elevations which occurred in 3.7% receiving 4 mg and 6.8-9.7% receiving 12 mg daily). 17090282
Quigley EM, Wald A, Fidelholtz J, Boivin M, Pecher E, Earnest D. Safety and tolerability of tegaserod in patients with chronic constipation: pooled data from two phase III studies. Clin Gastroenterol Hepatol 2006; 4: 605-13. (In a pooled analysis of 2 controlled trials of 12 weeks of tegaserod vs placebo, clinical chemistry results "were generally comparable across all treatment groups with no clinically significant trends observed"). 16678076
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to prokinetic agents or the 5-HT4 receptor agonists). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to prokinetic agents or the 5-HT4 receptor agonists). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, 1% were hepatic, but no prokinetic agent or 5-HT4 receptor agonist was listed among the 41 most commonly implicated agents). 21039766
Chey WD, Howden CW, Tack J, Ligozio G, Earnest DL. Long-term tegaserod treatment for dysmotility-like functional dyspepsia: results of two identical 1-year cohort studies. Dig Dis Sci 2010; 55: 684-97. (Among 780 patients with IBS treated with tegaserod for up to 1 year, most adverse events occurred in the first 6 months and "there were no clinically relevant changes in mean values" of routine biochemical results). 19957035
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to prokinetic agents or the 5-HT4 receptor agonists). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13], and flutamide [n=12: 7%]; prokinetic agents or the 5-HT4 receptor agonists were not listed). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to metoclopramide, but none to cisapride or other prokinetic agents). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Cisapride: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cisapride+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cisapride: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cisapride)